# Hematologic Growth Factors

## OVERVIEW

### Introduction

The hematologic growth factors (also called stimulating factors) are polypeptides that interact with cell surface receptors on hematologic progenitor cells causing their activation, proliferation and differentiation into mature circulating cells such as red blood cells, white blood cells, neutrophils, monocytes, macrophages and platelets. Several recombinant hematologic growth factors or agonists for their receptors have been produced that are useful in treating anemia, neutropenia and thrombocytopenia, particularly in patients with end stage renal disease or aplastic anemia or who have received cancer chemotherapy or a hematopoietic cell transplant. Most of the hematologic growth factors are recombinant polypeptides and have not been implicated in causing serum aminotransferase elevations or clinically apparent liver injury. A small molecule agonist of the thrombopoietin receptor (eltrombopag), however, has been linked to serum enzyme elevations during therapy, although not specifically to clinically apparent liver injury with jaundice.

Erythropoiesis stimulating agents include epoetin (e poe’ e tin), which is a recombinant form of erythropoietin, the 165 amino acid glycoprotein that induces red blood cell production from progenitors in the bone marrow. Erythropoietin is made in the kidneys and acts on progenitor erythroblasts through the erythropoietin receptor to cause proliferation and maturation into red cells. The major stimulus to erythropoietin synthesis is tissue hypoxia, but other factors modulate the response. Deficiency of erythropoietin is common in end stage renal disease and may also be present in premature infants and in patients with malignancies, chronic inflammation and cancer chemotherapy. Recombinant epoetin became available in the 1980’s and was shown to raise hemoglobin and hematocrit levels in patients with end stage renal disease on hemodialysis, as well as in patients receiving cancer chemotherapy and patients with AIDS on drugs that cause anemia. Epoetin alfa was approved for use to treat anemia in patients with renal disease and receiving cancer chemotherapy in 1989 and is now widely used. Indications have broadened to include reduction of allogeneic red cell transfusion in patients undergoing elective surgery and it is used off-label for other forms of anemia associated with relative erythropoietin deficiency. Longer acting formulations are also available including darbepoetin and peginesatide.

Colony stimulating factors increase white blood counts including neutrophils and macrophages/monocytes, and include granulocyte stimulating factor (G-CSF) and granulocyte-macrophage stimulating factor (GM-CSF). Human G-CSF is a 175 amino acid protein that induces the proliferation and maturation of neutrophils and is produced by multiple cell types including monocytes, fibroblasts, macrophages and stromal cells. It acts on specific receptors found on neutrophil progenitors. Human G-CSF is a 127 amino acid glycoprotein that acts upon both progenitors of both neutrophils and macrophages or monocytes. Recombinant forms of G-CSF (filgrastim and pegfilgrastim) and GM-CSF (sargramostim) have been developed and are approved for use in patients with malignancies after chemotherapy induced neutropenia and to support patients undergoing hematopoietic cell transplantation.

Thrombopoietin is a 332 amino acid protein that acts on its receptors on megakaryocytes to stimulate their proliferation and differentiation resulting in increases in circulating platelet counts. Recombinant forms of human thrombopoietin were found to be effective in raising platelet counts, but resulted in induction of neutralizing antibody in a proportion of patients which led to severe thrombocytopenia. For this reason, further development of recombinant thrombopoietin as a therapeutic agent was abandoned. Subsequently, a small molecule agonist of the thrombopoietin receptor was identified (eltrombopag) and shown to be effective in raising platelet counts in patients with idiopathic thrombocytopenic purpura (ITP), as well as in patients with aplastic anemia and patients with cirrhosis undergoing interferon-based therapy. In addition, a recombinant molecule of 4 copies of a small peptide that binds the thrombopoietin receptor fused to a copy of the human IgG1 heavy chain (romiplostim) was developed that has agonist activity to the receptor, despite lack of homology to thrombopoietin. Administration of romiplostim causes maturation of megakaryocytes and increased synthesis and release of platelets without inducing neutralizing antibody.

Background descriptions of the hematologic growth factors in current clinical use, their potential hepatotoxicity, mechanisms of liver injury and management along with pertinent references on safety are provided separately in LiverTox in the following Subclass records.

Drug Class: Hematologic Growth Factors

Drugs in the Subclass, Colony Stimulating Factors: Granulocyte Colony Stimulating Factors (G-CSF: Filgrastim and Pegfilgrastim), Granulocyte-Macrophage Colony Stimulating Factors (GM-CSF: Sargramostim)

Drugs in the Subclass, Erythropoiesis Stimulating Agents: Epoetin, Darbepoetin, Peginesatide

Drugs in the Subclass, Thrombopoietin Receptor Agonists and Thrombopoiesis Stimulators: Avatrombopag, Eltrombopag, Fostamatinib, Lusutrombopag, Romiplostim, Oprelvekin IL-11

Miscellaneous: Luspatercept